# Vericiguat

## OVERVIEW

### Introduction

Vericiguat is an orally available stimulator of soluble guanylate cyclase (sGC), a critical enzyme in the action of nitric oxide in inducing vascular relaxation, which is used in patients with chronic heart failure to reduce the risk of death and hospitalization. Vericiguat is associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent acute liver injury.

### Background

Vericiguat (ver" i sig' ue at) is an orally available, small molecule stimulator of soluble guanylate cyclase which is used in patients with chronic heart failure to reduce the risk of death and hospitalizations for heart failure. Soluble guanylate cyclase (sGC) is responsible for the relaxation of smooth muscle cells and vasodilation mediated by nitric oxide, an important mediator of vascular tone. Patients with heart failure have a relative deficiency of nitric oxide, and guanylate cyclase activity is reduced. Stimulation of guanylate cyclase activity by vericiguat reduces blood pressure and improves cardiac efficiency. In large, randomized placebo controlled trials, therapy of patients with heart failure with vericiguat reduced cardiovascular mortality and decreased hospitalizations and chronic morbidity. Vericiguat was approved for use in the United States in 2021. Current formal indications are restricted to patients with symptomatic chronic heart failure with a left ventricular cardiac ejection fraction of less than 45% who have required hospitalization or outpatient treatment with intravenous diuretics for control of symptoms of heart failure. Vericiguat is available as tablets of 2.5, 5 and 10 mg under the brand name Verquvo. The recommended starting dose is 2.5 mg once daily (taken with food) with doubling of the dose every two weeks to a maintenance dose of 10 mg daily. Common side effects include symptomatic hypotension and anemia. Rare, but potential severe adverse reactions are embryo-fetal toxicity and a boxed warning cautions that women of child bearing potential should be on an effective means of birth control for the duration of treatment and at least one month thereafter.

### Hepatotoxicity

In preregistration trials, serum aminotransferase elevations with mild bilirubin elevations were reported to occur in 2% of patients on vericiguat, but similar rates were reported with placebo therapy and the abnormalities resolved without dose modification or discontinuation of therapy. These abnormalities were considered the result of exacerbations of heart failure and congestive liver injury. There have been no published reports of clinically apparent liver injury with symptoms or jaundice attributed to vericiguat therapy, but the overall clinical experience with vericiguat has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which vericiguat might cause serum ALT elevations or liver injury is not known. Hepatic metabolism of vericiguat is via glucuronidation by UGT1A9 with minor involvement of the cytochrome P450 system. Vericiguat has not been associated with clinically significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on vericiguat therapy are usually self-limited and rarely require dose modification or discontinuation. No instances of clinically apparent acute hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to vericiguat. Cross sensitivity to liver related or other hypersensitivity reactions between vericiguat and other agents used in patients with heart failure (beta blockers, calcium channel blockers, angiotensin converting enzyme inhibitors, angiotensin receptor blockers) has not been demonstrated, and is unlikely to occur.

Drug Class: Cardiovascular Agents, Heart Failure Agents

Other Drugs in the Subclass, Guanylate Cyclase Inhibitors: Riociguat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vericiguat – Verquvo®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vericiguat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Vericiguat | 1350653-20-1 | C19-H16-F2-N8-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 16 June 2023

Abbreviations used: sGC, soluble guanylate cyclase.

Eschenhagen T. Therapy of heart failure. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 527-46. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214377Orig1s000IntegratedR.pdf (FDA website with product labels and the integrated review of the efficacy and safety of vericiguat that supported its approval for use in chronic heart failure mentions that liver injury arose in 25 of 2519 [1.0%] vericiguat-treated vs 12 of 2515 [0.5%] placebo-treated patients, but all cases had an alternative explanation, usually decompensated heart failure that improved despite continuing therapy; ALT elevations were listed as occur in 0.1% of treated patients and no treated patient died of liver failure [vs 3 placebo recipients]).
Armstrong PW, Pieske B, Anstrom KJ, Ezekowitz J, Hernandez AF, Butler J, Lam CSP, et al., VICTORIA Study Group. (2020). Vericiguat in patients with heart failure and reduced ejection fraction. N Engl J Med. (Among 5050 adults with symptomatic chronic heart failure and ejection fraction less than 45% who were treated with vericiguat [10 mg daily] or placebo, a composite endpoint of cardiovascular death or hospitalization for heart failure was less among vericiguat-treated subjects [35.5% vs 38.5%], and total and serious adverse event rates were similar, except for symptomatic hypotension [9.1% vs 7.9%] and anemia [7.6% vs 5.7%], while GGT elevations were less frequent with vericiguat [1.9% vs 2.6%]; no mention of ALT elevations or hepatotoxicity).
(2021). Vericiguat (Verquvo) for heart failure. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of vericiguat shortly after its approval for therapy of chronic heart failure in the US; mentions side effects of hypotension and anemia but does not mention ALT elevations or hepatotoxicity).
Butler J, Zheng Y, Khan MS, Bonderman D, Lund LH, deFilippi CR, Blaustein RO, et al., VICTORIA Study Group. (2023). Ejection fraction, biomarkers, and outcomes and impact of vericiguat on outcomes across EF in VICTORIA. JACC Heart Fail. (In a secondary analysis of the VICTORIA trial of vericiguat for heart failure [Armstrong 2020], a lower baseline left ventricular ejection fraction was associated with a higher rate of clinical outcomes, but similar if not higher rates of response to vericiguat and similar adverse event rates; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Vericiguat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Vericiguat/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vericiguat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vericiguat)